# Butterbur

## OVERVIEW

### Introduction

Butterbur is a popular herbal preparation that is used to treat migraine headaches, allergic rhinitis and respiratory illnesses. Butterbur is an extract of the roots of the butterbur bush and the extract has to be processed carefully to eliminate harmful pyrrolizidine alkaloids that occur naturally in the plant. Butterbur preparations processed to remove pyrrolizidine alkaloids do not appear to cause liver injury, either in the form of serum enzyme elevations during treatment or clinically apparent acute liver injury. However, recent cases of clinically apparent liver injury have been reported with use of several commercial preparations of butterbur, suspected to be due to residual pyrrolizidine alkaloid contamination.

### Background

Butterbur is a popular herbal product derived from the rhizomes and stems of the perennial butterbur bush (Petasites hybridus), a plant native to Europe. Butterbur is so named because its large leaves were used to wrap butter for storage. Butterbur extracts have been used for centuries in traditional medicine and purported uses were for plague, asthma, gastrointestinal and respiratory illnesses and cancer. Chemical components of butterbur extracts include sesquiterpene alcohol esters (petasitine, neopetasitine and isopetasitine), volatile oils, flavonoids and tannins. Extracts from butterbur leaves and stems can contain pyrrolizidine alkaloids (senecionine, integerrimine), which are toxic molecules capable of causing sinusoidal obstruction syndrome in animals as well as humans. Butterbur herbal products for oral use must be specially processed to remove any traces of pyrrolizidine alkaloids. Some evidence suggests that butterbur is effective in the treatment of migraine headaches and allergic rhinitis, but its long term efficacy and safety have not been established, and it is not specifically approved for these uses in the United States. Butterbur is available in a variety of formulations and the typical oral dosage is 100 to 150 mg per day in 2 to 3 divided doses. Side effects of butterbur are uncommon and mild, and include gastrointestinal upset, eructation, nausea, diarrhea, headache, dizziness, increased bleeding tendency and rash. In clinical trials, both serious and common side effects were often no more frequent with butterbur than placebo.

### Hepatotoxicity

Despite widespread use, butterbur extracts that are free of pyrrolizidine alkaloids have not been specifically linked to liver injury, either in the form of transient serum enzyme elevations or clinically apparent acute liver injury. However, because the processing of butterbur is critical to the safety of the herbal product, it has to be used with caution. After the European approval of a commercial butterbur product for use in migraine headache prevention, isolated reports of cholestatic hepatitis arose. Testing suggested that some preparations contained detectable amounts of pyrrolizidine alkaloids and some of the products were withdrawn. The relationship of the liver injury to butterbur remains controversial. A single publication summarizing clinical features of 10 cases reported to the sponsor has suggested that the liver injury was not related to the butterbur product, but 8 of the 10 cases were reasonably convincing and described a consistent clinical phenotype of fatigue, nausea and jaundice usually arising within 2 to 12 weeks of starting the product and marked by a hepatocellular pattern of injury and moderate-to-severe jaundice. Two cases resulted in urgent liver transplants, while the others apparently recovered, usually within 2 to 12 weeks. The clinical features of cases did not resemble sinusoidal obstruction syndrome and liver biopsy showed an acute hepatitis with variable degrees of cholestasis, but minimal steatosis or fibrosis and no mention of sinusoidal obstruction. Similar cases have not been described from other butterbur products.

Likelihood score: C (probable cause of clinically apparent liver injury, possibly caused by contaminants).

### Mechanism of Injury

The mechanism by which some preparations of butterbur might cause liver injury is not known but is likely due to a contaminant or mislabeling of the product. Butterbur-drug interactions have not been defined. While pyrrolizidine alkaloids are mentioned as the possible cause of liver injury associated with butterbur use, the clinical features of cases occurring during treatment suggested idiosyncratic liver injury rather than direct sinusoidal cell damage.

### Outcome and Management

Patients on butterbur who develop unexplained symptoms such as fatigue, nausea, abdominal pain or dark urine should have routine liver tests drawn and discontinue the use of the herb if there are any abnormalities.

Other Names: Petasites Extract, Purple Butterbur

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Butterbur – Generic

DRUG CLASS

Herbal and Dietary Supplements

COMPLETE LABELING

Fact Sheet at National Center for Complementary and Integrative Health (https://nccih.nih.gov/taxonomy/term/289)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Butterbur | 90082-63-6 | Herbal Extract | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 18 February 2019

Abbreviations used: HDS, herbal and dietary supplements

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; butterbur is not discussed).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements published in 2007; butterbur is not listed).
Petasites. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 646-8. (Compilation of short monographs on herbal medications and dietary supplements).
Grossman W, Schmidramsl H. An extract of Petasites hybridus is effective in the prophylaxis of migraine. Altern Med Rev 2001; 6: 303-10. (Among 60 patients with migraine headaches enrolled in a 4 month controlled trial, monthly migraine frequency decreased more with butterbur [3.5 to 1.7] than placebo [2.9 to 2.6]) and “no adverse events were reported in the drug group”). 11410074
Danesch U, Rittinghausen R. Safety of a patented special butterbur root extract for migraine prevention. Headache 2003; 43: 76-8. (Summary of tolerability and safety results from pre- and postmarketing studies of a commercial butterbur product, found adverse event rates were similar in butterbur as placebo recipients, and surveillance identified only a low rate of complaints of eructation and skin rash; no mention of ALT levels but states that a single instance of reversible cholestatic hepatitis was attributed to a hypersensitivity reaction to butterbur in postmarketing surveillance studies; no details provided). 12864764
Brattström A. A newly developed extract (Ze 339) from butterbur (Petasites hybridus L.) is clinically efficient in allergic rhinitis(hay fever). Phytomedicine 2003; 10 Suppl 4: 50-2. (Among 317 patients with allergic rhinitis treated with butterbur, cetirizine or placebo for 2 weeks in 2 randomized controlled trials, “the incidence and type of adverse events were indistinguishable across the herbal treatment groups and placebo”). 12807342
Lipton RB, Göbel H, Einhäupl KM, Wilks K, Mauskop A. Petasites hybridus root (butterbur) is an effective preventive treatment for migraine. Neurology 2004; 63: 2240-4. (Among 245 adults with chronic migraines treated with butterbur [50 or 75 mg] or placebo twice daily for 4 months, migraine frequency rates decreased by 32% and 45% vs 28%, while adverse events that were more frequent with butterbur included mild gastrointestinal complaints identified in 26% and 22% vs 7%; no mention of ALT elevations or hepatotoxicity). 15623680
Schapowal A; Petasites Study Group. Butterbur Ze339 for the treatment of intermittent allergic rhinitis: dose-dependent efficacy in a prospective, randomized, double-blind, placebo-controlled study. Arch Otolaryngol Head Neck Surg 2004; 130: 1381-6. (Among 186 patients with allergic rhinitis treated with butterbur or placebo 2 or 3 times daily for 2 weeks, response rates were higher with butterbur [91% and 71% vs 46%] while adverse event rates were similar; no mention of ALT changes or hepatotoxicity). 15611396
Schapowal A; Study Group. Treating intermittent allergic rhinitis: a prospective, randomized, placebo and antihistamine-controlled study of Butterbur extract Ze 339. Phytother Res 2005; 19: 530-7. (Among 330 patients with allergic rhinitis treated with a commercial butterbur product [Ze 339] vs fexofenadine vs placebo for 2 weeks, the response rates by day 14 were 32% vs 33% vs 5%, and there were no serious adverse events and no change in ALT, AST or GGT levels with treatment). 16114089
Pothmann R, Danesch U. Migraine prevention in children and adolescents: results of an open study with a special butterbur root extract. Headache 2005; 45: 196-203. (Among 108 children [ages 6 to 17 years] with migraines treated in an open-label trial with a commercial preparation of butterbur [Petadolex] for 4 months, the frequency of migraines was reduced by 63% and side effects were uncommon and mild [eructation in 4%]; there were no severe adverse reactions and no mention of ALT elevations or hepatotoxicity). 15836592
Käufeler R, Polasek W, Brattström A, Koetter U. Efficacy and safety of butterbur herbal extract Ze 339 in seasonal allergic rhinitis: postmarketing surveillance study. Adv Ther 2006; 23: 373-84. (Summary of two uncontrolled open-label trials of a commercial preparation of butterbur [Ze 339] in 580 patients with allergic rhinitis found that 90% of treated subjects reported improvements in symptoms). 16751170
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry, none of which were attributed to butterbur). 19650152
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; butterbur is not listed as a potentially hepatotoxic botanical). 19826971
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to HDS, but none incriminated butterbur). 20949552
Stickel F, Kessebohm K, Weimann R, Seitz HK. Review of liver injury associated with dietary supplements. Liver Int 2011; 31: 595-605. (Review of liver injury from HDS focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, Noni juice, and Chinese herbs; does not mention butterbur). 21457433
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs and supplements, none of which contained butterbur). 22928722
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to butterbur). 25043597
Prieto J. Update on the efficacy and safety of Petadolex, a butterbur extract for migraine prophylaxis. Bot Target Ther 2014; 4: 1-9. Not in PubMed (Review of the efficacy and safety of butterbur extract for migraine prophylaxis; mentions that the controlled trials of commercial preparations of butterbur reported low rates of mild adverse events, but that postmarketing studies from Europe have identified as many as 40 instances of clinically apparent liver injury [thought to be due to pyrrolizidine alkaloids in the products despite extraction methods thought to remove them]; these liver related adverse events led to the withdrawal of several butterbur products in Switzerland and Germany, but they are still available commercially in the US and via the internet).
Teschke R, Eickhoff A, Schulze J, Wolff A, Frenzel C. Petadolex, a herbal extract for migraine prophylaxis with spontaneous case reports of disputed liver injury: robust causality evaluation by RUCAM. Eur J Pharmaceut Med Res 2016; 3 (12): 154-77. Not in PubMed (Clinical description of cases of liver injury attributed to butterbur [Petadolex] reported to the manufacturer from Germany and Austria; includes 8 reasonably convincing cases: 7 women, 1 man; ages 24 to 58 years; presenting with hepatocellular injury [bilirubin 5.7-14.0 mg/dL, ALT 220-4458 U/L, Alk P 107-252 U/L], resolving within 2-16 weeks in most but 2 requiring liver transplantation).
Tepper SJ. Nutraceutical and other modalities for the treatment of headache. Continuum (Minneap Minn) 2015; 21 (4 Headache): 1018-31. (Review of the mechanism of action, clinical efficacy and safety of herbal products used to treat or prevent migraine; mentions that butterbur may have some efficacy, but some commercial preparations have been found to be hepatotoxic). 26252588
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: a tabular listing and clinical characteristics. Int J Mol Sci 2016; 17: 537. (Listing of published cases of liver injury from HDS products does not mention butterbur). 27070596
Drugs for migraine. Med Lett Drugs Ther 2017; 59 (1514): 27-32. (Concise review of the treatment and prevention of migraine headaches; mentions that butterbur has been reported to decrease rates of migraine headaches but may be hepatotoxic and is best avoided). 28170366
Orr SL. The evidence for the role of nutraceuticals in the management of pediatric migraine: a review. Curr Pain Headache Rep 2018; 22: 37. (Review of the efficacy and safety of nutraceuticals for migraine; mentions that butterbur extracts have shown efficacy in reducing the frequency of migraine in small clinical trials, but postmarketing surveillance revealed several cases of hepatotoxicity attributed to presence of pyrrolizidine alkaloids in some of commercial preparations). 29619575
Sprenger T, Viana M, Tassorelli C. Current prophylactic medications for migraine and their potential mechanisms of action. Neurotherapeutics 2018; 15: 313-23. (Review of the clinical efficacy and safety of drugs for prevention of migraine headaches discusses two herbal products, feverfew and butterbur for which only moderate evidence for effectiveness has been published). 29671241

## OTHER REFERENCE LINKS

1. Recent References on Butterbur: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=cascara+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Butterbur: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=cascara)